# Fulvestrant

## OVERVIEW

### Introduction

Fulvestrant is a steroidal antiestrogen that is used in the treatment of hormone-receptor positive metastatic breast cancer. Fulvestrant therapy can be associated with serum enzyme elevations, but has yet to be linked to instances of clinically apparent acute liver injury in the published literature.

### Background

Fulvestrant (ful ves' trant) is a steroidal antiestrogen that is potent and direct antagonist or "down regulator" of the estrogen receptor. Fulvestrant is a synthetic derivative of estradiol and binds to the estrogen receptor with 100 times more potency than tamoxifen. It not only blocks the effects of estrogen, but also alters the structure of the estrogen receptor and further decreases the intracellular effects of estrogen. Unlike tamoxifen, fulvestrant is a pure antiestrogen and has no estrogen receptor agonist activity. Fulvestrant has been found to be as effective as tamoxifen as a first line agent to treat metastatic breast cancer, and is similar in efficacy to the aromatase inhibitors in women with progressive disease despite tamoxifen therapy. Fulvestrant was approved for use in the United States in 2002. Current indications are for treatment of postmenopausal women with hormone-receptor positive metastatic breast cancer who have had disease progression despite antiestrogen therapy. Fulvestrant is available as a liquid solution in 5 mL vials of 250 mg for intramuscular injection under the brand name Faslodex. The usual dose for treating breast cancer is 500 mg given in two intramuscular injections in the buttocks (slowly, over 1-2 minutes) on days 1, 15 and 29, and then monthly thereafter. Common side effects include injection site pain and reactions, nausea, anorexia, fatigue, headache, backache, muscle pains, host flashes, cough, dyspnea and constipation. Rare, but potentially severe side effects include hypersensitivity reactions.

### Hepatotoxicity

Fulvestrant therapy is said to be associated with serum enzyme elevations in up to 15% of patients, but the elevations are generally asymptomatic, transient and mild, rarely requiring dose adjustment or discontinuation. ALT elevations above 5 times the upper limit of normal occurred in only 1% to 2% of patients. However, specifics on the timing and course of serum enzyme elevations during fulvestrant therapy have not been described. In addition, no cases of clinically apparent liver injury with jaundice were reported in the prelicensure controlled trials of fulvestrant and none have been published since its approval in the United States and more wide-scale use. Nevertheless, the product label for fulvestrant mentions that "hepatitis and liver failure have been reported infrequently (<1%)". Unlike tamoxifen, fulvestrant has not been linked to steatosis or nonalcoholic fatty liver, nor has it been found to cause the bland cholestasis that can occur with oral contraceptives or high dose estrogen therapy.

Likelihood score: E* (unproven but suspected cause of clinically apprent liver injury).

### Mechanism of Injury

Fulvestrant is extensively metabolized in the liver, largely via the cytochrome P450 enzyme CYP 3A4, but has not been found to have significant drug-drug interactions. Nevertheless, hepatotoxicity might be caused by a toxic or immunogenic metabolic product of fulvestrant.

### Outcome and Management

While fulvestrant has been reported to cause serum enzyme elevations during therapy, it has not been convincing linked to cases of clinically apparent liver injury, acute liver failure, chronic hepatitis, fatty liver or vanishing bile duct syndrome. There is no reason to suspect that there is cross sensitivity to liver injury between fulvestrant and other antiestrogens such as tamoxifen and the aromatase inhibitors.

Drug Class: Antineoplastic Agents, Antiestrogens

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Fulvestrant – Generic, Faslode®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Fulvestrant)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Fulvestrant | 129453-61-8 | C32-H47-F5-O3-S | Image of Fulvestrant Chemical Structure
Estradiol(17-β) | 50-28-2 | C18-H24-O2 | Image of Fulvestrant Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 06 February 2018

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 699. (Expert review of hepatotoxicity published in 1999; fulvestrant is not discussed).
Chitturi S, Farrell GC. Estrogen receptor antagonists. Adverse effects of hormones and hormone antagonists on the liver. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 610-2. (Review of hepatotoxicity of estrogens and antiestrogens discusses tamoxifen but not fulvestrant).
Moy B, Lee RJ, Smith M. Anti-estrogen therapy. Natural products in cancer chemotherapy. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1756-9. (Textbook of pharmacology and therapeutics).
Fulvestrant (Faslodex) for advanced breast cancer. Med Lett Drugs Ther 2002; 44: 65-6. (Concise summary of the mechanisms of action, pharmacokinetics, efficacy, safety and costs of fulvestrant for advanced breast cancer; no mention of ALT elevations or hepatotoxicity). 12138378
Bross PF, Cohen MH, Williams GA, Pazdur R. FDA drug approval summaries: fulvestrant. Oncologist 2002; 7: 477-80. (Review of the evidence for safety and efficacy of fulvestrant which was the basis for the FDA approval; in 2 controlled trials comparing fulvestrant to anastrozole for 2 years, response rates were similar and common side effects of fulvestrant were injection site pain, hot flashes, fatigue, headache, nausea, diarrhea and rash; no mention of ALT elevations or clinically apparent liver injury). 12490735
Robertson JF, Llombart-Cussac A, Rolski J, Feltl D, Dewar J, Macpherson E, Lindemann J, et al. Activity of fulvestrant 500 mg versus anastrozole 1 mg as first-line treatment for advanced breast cancer: results from the FIRST study. J Clin Oncol 2009; 27: 4530-5. (Among 205 women with estrogen-receptor positive advanced breast cancer treated with fulvestrant [500 mg doses] or anastrozole, tolerability and drop-out rates were similar during the first 6 months; no mention of ALT elevations or hepatotoxicity). 19704066
Flemming J, Madarnas Y, Franek JA. Fulvestrant for systemic therapy of locally advanced or metastatic breast cancer in postmenopausal women: a systematic review. Breast Cancer Res Treat 2009; 115: 255-68. (Systematic review of 4 controlled trials of fulvestrant versus anastrozole or exemestane, found similar rates of efficacy and tolerance; no mention of ALT elevations or hepatotoxicity). 18683044
Pritchard KI, Rolski J, Papai Z, Mauriac L, Cardoso F, Chang J, Panasci L, et al. Results of a phase II study comparing three dosing regimens of fulvestrant in postmenopausal women with advanced breast cancer (FINDER2). Breast Cancer Res Treat 2010; 123: 453-61. (Controlled trial of 3 doses of fulvestrant [250 to 500 mg] in 94 women with metastatic breast cancer after failure of antiestrogen therapy found similar rates of efficacy and adverse events; no mention of ALT elevations or hepatotoxicity). 20632084
Howell A, Bergh J. Insights into the place of fulvestrant for the treatment of advanced endocrine responsive breast cancer. J Clin Oncol 2010; 28: 4548-50. (Editorial on the pharmacokinetics of fulvestrant describing the evidence that a higher dose [500 mg] is slightly more effective and just as well tolerated as the initially approved dose [250 mg] in prolonging progression-free survival). 20855842
Robertson JF, Lindemann JP, Llombart-Cussac A, Rolski J, Feltl D, Dewar J, Emerson L, et al. Fulvestrant 500 mg versus anastrozole 1 mg for the first-line treatment of advanced breast cancer: follow-up analysis from the randomized 'FIRST' study. Breast Cancer Res Treat 2012; 136: 503-11. (Among 205 women with estrogen receptor positive advanced breast cancer treated with fulvestrant [500 mg] or anastrozole, time to progression was longer with fulvestrant and no new safety concerns were identified; ALT elevations were not mentioned and there were no liver related serious adverse events). 23065000
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none of the 96 were attributed to fulvestrant or any other antiestrogen). 23419359
Di Leo A, Jerusalem G, Petruzelka L, Torres R, Bondarenko IN, Khasanov R, Verhoeven D, et al. Final overall survival: fulvestrant 500 mg vs 250 mg in the randomized CONFIRM trial. J Natl Cancer Inst 2014; 106: djt337. (Among 736 women with metastatic estrogen-receptor positive breast cancer treated with either 250 or 500 mg of fulvestrant monthly, there were no important differences in adverse reactions and no serious hepatic adverse events). 24317176
Ellis AJ, Hendrick VM, Williams R, Komm BS. Selective estrogen receptor modulators in clinical practice: a safety overview. Expert Opin Drug Saf 2015: 14: 921-34. (Overview of the safety of estrogen receptor modulations used to treat or prevent breast cancer and for osteoporosis includes discussion of tamoxifen, raloxifene and fulvestrant and focuses upon cardiovascular and cancer related safety issues, with no mention of ALT elevations or hepatotoxicity). 25936229
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 4 were attributed to tamoxifen, 2 to exemestane and 1 to letrozole, but none to fulvestrant). 25754159
Ellis MJ, Llombart-Cussac A, Feltl D, Dewar JA, Jasiówka M, Hewson N, Rukazenkov Y, Robertson JF. Fulvestrant 500 mg versus anastrozole 1 mg for the first-line treatment of advanced breast cancer: overall survival analysis from the phase II FIRST study. J Clin Oncol 2015; 33: 3781-7. (Among 205 women with advanced breast cancer treated with fulvestrant or anastrozole, overall median survival was 54 vs 48 months and "no new safety issues were observed"; no mention of ALT elevations or hepatotoxicity). 26371134
Zhang Q, Shao Z, Shen K, Li L, Feng J, Tong Z, Gu K, et al. Fulvestrant 500 mg vs 250 mg in postmenopausal women with estrogen receptor-positive advanced breast cancer: a randomized, double-blind registrational trial in China. Oncotarget 2016; 7: 57301-9. (Among 221 Chinese postmenopausal women with advanced breast cancer treated with fulvestrant [250 vs 500 mg daily], median progression free survival was higher with the higher dose [8 vs 4 months] while overall side effect rates were similar, and there were no discontinuations for severe adverse events or mention of liver related side effects). 27359058
Lerebours F, Rivera S, Mouret-Reynier MA, Alran S, Venat-Bouvet L, Kerbrat P, Salmon R, et al. Randomized phase 2 neoadjuvant trial evaluating anastrozole and fulvestrant efficacy for postmenopausal, estrogen receptor-positive, human epidermal growth factor receptor 2-negative breast cancer patients: Results of the UNICANCER CARMINA 02 French trial (UCBG 0609). Cancer 2016; 122: 3032-40. (Among 116 women with operative breast cancer given adjuvant therapy with anastrozole or fulvestrant, both therapies were well tolerated with no serious adverse events or mention of ALT elevations or liver related adverse events). 27315583
Robertson JFR, Bondarenko IM, Trishkina E, Dvorkin M, Panasci L, Manikhas A, Shparyk Y, et al. Fulvestrant 500 mg versus anastrozole 1 mg for hormone receptor-positive advanced breast cancer (FALCON): an international, randomised, double-blind, phase 3 trial. Lancet 2016; 388 (10063): 2997-3005. (Among 462 women with advanced breast cancer treated with fulvestrant vs anastrozole, median progression free survival was higher with fulvestrant [16.6 vs 13.8 months], while overall side effect rates were similar, ALT elevations arising in 7% vs 3%, but there were no liver related serious adverse events). 27908454
Baselga J, Im SA, Iwata H, Cortés J, De Laurentiis M, Jiang Z, Arteaga CL, et al. Buparlisib plus fulvestrant versus placebo plus fulvestrant in postmenopausal, hormone receptor-positive, HER2-negative, advanced breast cancer (BELLE-2): a randomised, double-blind, placebo-controlled, phase 3 trial. Lancet Oncol 2017; 18: 904-16. (Among 1147 postmenopausal women with advanced breast cancer treated with fulvestrant with or without buparlisib [pan PI3 inhibitor], prgression free survival was slightly higher in the buparlisib group, although adverse events were also more common). 28576675
Di Leo A, Johnston S, Lee KS, Ciruelos E, Lønning PE, Janni W, O'Regan R, et al. Buparlisib plus fulvestrant in postmenopausal women with hormone-receptor-positive, HER2-negative, advanced breast cancer progressing on or after mTOR inhibition (BELLE-3): a randomised, double-blind, placebo-controlled, phase 3 trial. Lancet Oncol 2018; 19: 87-100. (Among 432 women with refractory, advanced breast cancer treated with fulvestrant with or without buparlisib, progression free survival was similar in both groups, while side effects were move frequent with the combination, ALT elevations arising in 39% vs 7% and rising above 5 times ULN in 22% vs 3%). 29223745

## OTHER REFERENCE LINKS

1. Recent References on Fulvestrant: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Fulvestrant+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Fulvestrant: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Fulvestrant)